# Elinzanetant

## OVERVIEW

### Introduction

Elinzanetant is an orally available neurokinin 1 and 3 receptor antagonist that is used to treat women with vasomotor symptoms (such as hot flashes) due to menopause. Elinzanetant is associated with a low rate of serum aminotransferase elevations during therapy but has not been linked to instances of clinically apparent liver injury with jaundice.

### Background

Elinzanetant (e lin zan eh tant) is a neurokinin (NK) 1 and 3 receptor antagonist that is used to treat moderate to severe vasomotor symptoms due to menopause. The NK1 and NK3 receptors are found on neurons in the thermoregulatory center of the brain, are activated by binding to neurokinin B, and are inhibited by circulating estrogen levels. During menopause, estrogen levels fall, and neurokinin B binding is unopposed which leads to altered thermoregulation manifested by hot flashes, episodes of sensations of heat in the upper body, lasting 1 to 5 minutes arising multiple times per day and which can be accompanied by flushing, chills, perspiration, clamminess, fatigue, and anxiety: symptoms that can interfere with activities of daily living and quality of life. Conventional therapy of menopausal vasomotor symptoms is estrogen replacement, which is effective but can be associated with adverse events including an increased risk of hormone-sensitive cancers, thromboembolism, and an increased risk of heart attack and stroke. Elinzanetant is a small molecule, non-hormonal inhibitor of neurokinin binding and has been shown to decrease both the frequency and the severity of the vasomotor symptoms. Elinzanetant was approved for use in the United States in 2025 and is available in capsules of 60 mg under the brand name Lynkuet. Elinzanetant was the second NK inhibitor approved for use, the first being fezolinetant [Veozah] an inhibitor of NK1 in 2023. The recommended dose of elinzanetant is 120 mg once daily. Current indications are for moderate to severe vasomotor symptoms due to menopause. Contraindications include severe hepatic or renal impairment and concurrent therapy with strong inhibitors of CYP 3A4, the cytochrome P450 enzyme primarily responsible for its metabolism. Elinzanetant is generally well tolerated. Side effects can include headache, fatigue, dizziness, vertigo, somnolence, diarrhea, abdominal pain, rash, muscle spasms, and serum aminotransferase elevations.

### Hepatotoxicity

In preregistration clinical trials, serum ALT or AST elevations above 3 times the upper limit of normal (ULN) occurred in 0.6% of patients taking elinzanetant vs 0.4% of placebo recipients. The elevations were asymptomatic and transient, resolving promptly after stopping therapy and sometimes despite drug continuation. Nevertheless, the elevations appeared to be related to therapy and arose most frequently during the first few months of treatment. In the safety profiles of elinzanetant therapy in 713 women enrolled in 3 controlled trials, there were no instances of clinically apparent liver injury with jaundice. Nevertheless, the clinical experience with elinzanetant outside of controlled trials has been limited. Fezolinetant, the initial NK inhibitor approved for treatment of menopausal symptoms was found to cause rare instances of liver injury with jaundice within a year of its release. For these reasons the product label for elinzanetant recommends testing for routine liver tests before treatment, again at 3 months after starting the drug, and monitoring patients for symptoms of liver injury regularly throughout therapy.

Likelihood score: E* (unproven but suspected rare cause of clinically apparent liver injury).

### Mechanism of Liver Injury

The mechanism by which elinzanetant might cause liver injury is unclear. Elinzanetant is metabolized in the liver primarily by CYP 3A4 and moderate and strong inhibitors of this isoenzyme can result in higher drug levels and possibly increased rate of adverse events. The dose of elinzanetant should be lowered by half in patients on moderate CYP 3A4 inhibitors (such as ciprofloxacin, grapefruit juice, fluconazole, and verapamil) and the drug should not be used in patients receiving strong inhibitors (such as ritonavir, cobicistat, itraconazole, and clarithromycin).

### Outcome and Management

The product label for elinzanetant has a warning about serum aminotransferase elevations and recommends assessing clinical symptoms and laboratory features of liver disease before starting therapy and repeating tests after 3 months of treatment. In addition, patients should be monitored for symptoms regularly. Elinzanetant should be discontinued if ALT or AST levels rise to above 5 times ULN or above 3 times ULN if symptoms or jaundice are present. Patients found to have serum aminotransferase elevations should be followed carefully until they resolve. Elinzanetant is contraindicated in women with end stage liver disease or renal failure and should be used with caution in those with liver test abnormalities at baseline.

Drug Class: Drugs for menopausal symptoms: Estrogens, Fezolinetant

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Elinzanetant – Lynkuet®

DRUG CLASS

Agents for Menopausal Symptoms

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/drugInfo.cfm?setid=f42884ff-7dff-419c-8a0c-affe2ed73818)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULAS AND STRUCTURES

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Elinzanetant | 929046-33-3 | C33H35F7N4O3

## ANNOTATED BIBLIOGRAPHY

References updated: 20 December 2025

Abbreviations: NK, neurokinin; CYP, cytochrome P450.

Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999. (Review of hepatotoxicity published in 1999 before the availability of NK receptor antagonists).
FDA. 2025. Integrated Review. https://www.accessdata.fda.gov/scripts/cder/daf/index.cfm?event=BasicSearch.process (FDA website with product label and integrated clinical review of data on elinzanetant provided by the sponsor in support of its approval as therapy of the vasomotor symptoms of menopause, mentions that liver test abnormalities were seen during treatment and recommended that “hepatic transaminase should be measured prior to initiating therapy and 3 months after initiation”).
Drugs for menopausal symptoms. Med Lett Drugs Ther. 2024;66(1697):33-38.. (Concise review of drugs that are approved for therapy of genitourinary and vasomotor symptoms related to menopause, briefly discusses fezolinetant, a non-hormonal therapy for vasomotor symptoms, which can cause adverse events such as abdominal pain, diarrhea, insomnia, back pain, and hepatic aminotransferase elevations; elinzanetant was approved after this summary and is not mentioned). 38412276
Pinkerton JV, Simon JA, Joffe H, Maki PM, Nappi RE, Panay N, Soares CN, et al. Elinzanetant for the treatment of vasomotor symptoms associated with menopause: OASIS 1 and 2 randomized clinical trials. JAMA. 2024;332:1343–54.. (Among 793 women with moderate to severe menopausal vasomotor symptoms enrolled in two 12-week, randomized placebo-controlled trials, those treated with elinzanetant [120 mg] had a greater decrease in the daily number and severity of symptoms after 12 weeks, and “there were no cases of liver enzyme elevations meeting criteria for liver injury”). 39172446
Cardoso F, Parke S, Brennan DJ, Briggs P, Donders G, Panay N, Haseli-Mashhadi N, et al. Elinzanetant for vasomotor symptoms from endocrine therapy for breast cancer. N Engl J Med. 2025;393:753-763.. (Among 474 women with moderate to severe vasomotor symptoms due to endocrine therapy of breast cancer treated with elinzanetant [120 mg] or placebo daily for 12 weeks, the average number of daily symptoms decreased more with elinzanetant [-7.8] than placebo [-4.2] and adverse events arose in 70% vs 62% that were severe in 4.1% vs 2.5%, while serum ALT levels above 3 times ULN arose in 3 [1%] vs none and one treated patient had a concurrent rise in bilirubin but a safety monitoring board concluded that elinzanetant did not appear to have a “substantive hepatotoxicity signal”). 40454634
Panay N, Joffe H, Maki PM, Nappi RE, Pinkerton JV, Simon JA, Soares CN, et al. Elinzanetant for the treatment of vasomotor symptoms associated with menopause: a phase 3 randomized clinical trial. JAMA Intern Med. 2025;185:1319-1327.. (Among 628 women with moderate-to-severe menopausal vasomotor symptoms treated with elinzanetant [120 mg] or placebo daily for 52 weeks, the mean frequency of symptom frequency decreased from 6.7 to 1.4 with elinzanetant vs 6.8 to 3.5 per day with placebo while adverse events included headache, fatigue, somnolence, dizziness, diarrhea, and rash, and ALT elevations above 3 times ULN arose in 2.3% vs 1.6%, but none were accompanied by jaundice). 40920404
Mehta JM, Millstine DM, Manson JE. The growing promise of elinzanetant for treatment of menopausal symptoms-sustained relief without hormones. JAMA Intern Med. 2025;185:1328-1329.. (Editorial in response to Panay [2025] mentions that elinzanetant may be a safer option compared to fezolinetant). 40920369
Lee A. Elinzanetant: first approval. Drugs. 2025 Nov 12. Epub ahead of print.. (Review of the mechanism of action, history of development, pharmacology, clinical efficacy and safety of elinzanetant does not mention ALT elevations or hepatotoxicity). 41222830
Elinzanetant (Lynkuet) for menopausal vasomotor symptoms. Med Lett Drugs Ther. 2025;67(1744):203-206.. (Concise review of the mechanism of action, clinical efficacy, safety, and cost of elinzanetant shortly after its approval in the United States, mentions that ALT elevations arose in only 0.6% of patients in clinical trials for 12 weeks but that hepatotoxicity was not seen with long-term use). 41396431

## OTHER REFERENCE LINKS

1. Recent References on Elinzanetant: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Elinzanetant/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))

2. Trials on Elinzanetant: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Elinzanetant)